# Metamizole [Dipyrone]

## OVERVIEW

### Introduction

Metamizole, also known as dipyrone, is an oral analgesic that is not available in the United States but is available over-the-counter in many countries of the world. Therapy with metamizole has been associated with rare severe bone marrow and liver adverse events including agranulocytosis, acute hepatitis, and acute liver failure.

### Background

Metamizole (me tam’ i zole), also known as dipyrone (dye’ pir on), is a widely used oral agent for moderate-to-severe pain, fever, and spasm that is banned and not available in the United States but is widely used and available over-the-counter in other selected countries and areas of the world, including Germany, Russia, Mexico, South America, Israel, and China. Metamizole has analgesic, antipyretic, and antispasmodic activity and is often referred to as a non-steroidal anti-inflammatory drug (NSAID). First patented in 1922 and marketed under the names Novalgin and Analgin, metamizole became a popular and widely prescribed analgesic. However, because of reports of agranulocytosis, it was withdrawn from the market in the United States and subsequently in the United Kingdom, France, Canada, India, Japan, and Australia. Nevertheless, it remained available by prescription as well as over the counter in many other countries and has been reported in the United States in patients who acquired it from abroad (Mexico, Brazil, China). Metamizole is a well tolerated drug and has fewer common side effects than aspirin and other typical NSAIDs such as ibuprofen and naproxen. Metamizole also has antipyretic and spasmolytic activities and was frequently used for postoperative pain and fever. The European Medicines Agency conducted an extensive review of its efficacy, safety, and benefit-to-risk ratio, concluding that metamizole was generally safe and that agranulocytosis and liver injury occurred with its use, but rarely and not much more commonly than with other over the counter analgesics. In selected countries, metamizole is available in tablets for oral use, suppositories for rectal administration, and in solution for intramuscular or intravenous use. The recommended oral dosage is 500 to 1,000 mg orally 1 to 4 times a day as needed. Dipyrone in solution is also available for intramuscular or intravenous use. Common adverse events include nausea, vomiting, headache, weakness, fever, abdominal pain, somnolence, vertigo, spams, neutropenia, renal dysfunction, and rash. Rare but potentially serious adverse events include hypersensitivity reactions, urticaria, angioedema, anaphylaxis, Stevens-Johnson syndrome, toxic epidermal necrolysis, interstitial nephritis, tachycardia, hypotension, shock, and agranulocytosis (estimated incidence ranging from 1:10,000 to 1:1,000,000 exposed persons).

### Hepatotoxicity

Cases of liver injury from metamizole were rarely reported before 2019 when two case series of liver injury from its use including fatalities were reported from Germany. Reassessments were conducted by the European Medicines Agency based upon accumulation of more than 40 cases. Within a year or two, reviews of more than 50 cases of clinically apparent liver injury due to metamizole were described. The clinical features of metamizole-associated liver injury have varied greatly, some being hyper-acute with rapid onset of fever, rash, and jaundice after the initial or first several doses. These cases may represent hypersensitivity reactions such as hepatic involvement in DRESS syndrome, toxic epidermal necrolysis, or Stevens-Johnson syndrome.

In other instances, metamizole induced liver injury arose during more prolonged therapy after a latency of 2 to 16 weeks, manifested by the gradual onset of fatigue, nausea, anorexia, and right upper quadrant discomfort followed by dark urine and jaundice. Serum enzyme elevations were typically hepatocellular and, less commonly, mixed and even cholestatic. Recovery was usually rapid once metamizole was stopped and rarely required immunosuppressive therapy. In a proportion of patients, however, serum aminotransferase levels can be quite high at onset with minimal increases in alkaline phosphatase and with continued rises serum bilirubin levels, rapid onset of liver failure, and need for emergency liver transplantation or death. Many of these cases are “autoimmune hepatitis-like” and autoantibodies including ANA and AMA are frequently detected. A distinctive immune marker known as liver kidney microsomal antibody (anti-LKM) has been found in a high proportion of cases, at least when tested by immunofluorescence. Serum IgG levels are usually normal or only mildly elevated, and liver histology does not resemble typical spontaneous autoimmune hepatitis. As might be expected, the fatality rate appears to be at least 10% in cases with hepatocellular injury and jaundice. There have been multiple reports of fatalities and need for liver transplants due to liver injury caused by metamizole. Recurrence upon re-exposure is usually abrupt in onset and more severe in course than the initial episode.

The incidence of clinically apparent liver injury from metamizole is not known but be as high as 1 per 1000 persons.

Likelihood score: A (well described although rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of the liver injuries from metamizole are likely to be immune mediated and the two patterns of injury suggest an immediate hypersensitivity reaction and a more delayed adaptive immune mediated injury. Metamizole can cause hypersensitivity reactions with no or only very mild liver injury including urticaria and rash, Stevens-Johnson syndrome, and toxic epidermal necrolysis. Patients who develop agranulocytosis due to metamizole frequently have accompanying liver injury that is generally mild and overshadowed by the hematologic events.

### Outcome and Management

Metamizole should be discontinued immediately in any patient presenting with acute liver injury and held until the diagnosis is clear. While metamizole is not available in the United States, immigrants from areas of the world where it is used may bring or order metamizole (frequently called dipyrone) from their countries of origin and may not report its use to physicians because it is considered a common, safe, over-the-counter medication. There is little evidence that immunosuppressive therapy is beneficial, although it is often used when improvement does not occur rapidly upon withdrawal of metamizole. The drug should not be restarted in anyone with suspected metamizole liver injury. Furthermore, patients taking the drug should be encouraged to discontinue it because of its propensity to cause serious side effects.

Drug Class: Nonsteroidal Antiinflammatory Drugs (NSAIDs)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Metamizole (Dipyrone) – Generic

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

LABELING INFORMATION (https://www.ema.europa.eu/en/documents/referral/metamizole-article-31-referral-annex-iii_en.pdf)

Product labeling at European Medicines Agency

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Metamizole | 68-89-3 | C13-H17-N3-O4-S

## ANNOTATED BIBLIOGRAPHY

References updated: 10 August 2025

Abbreviations: NSAIDS, nonsteroidal anti-inflammatory drugs, ULN, upper limit of the normal range.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review and compendium of hepatotoxicity published in 1999 does not mention dipyrone or metamizole).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook of hepatotoxicity published in the United States in 2013, does not mention dipyrone or metamizole).
Grosser T, Smyth EM, FitzGerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 685-709. (Textbook of pharmacology and therapeutics does not include mention or discussion of dipyrone or metamizole).
Federmann G, Becker EW, Tautorat H, Penschuck C, Berg PA. [Demonstration by lymphocyte transformation test of the allergic genesis in a case of acute hepatitis]. Dtsch Med Wochenschr. 1988;113:1676-9. German. (50 year old man developed jaundice shortly after cholecystectomy and a single oral dose of metamizole for postoperative fever and pain having received this medication several times in the past for arthritis [bilirubin rising rapidly to 43.9 mg/dL, ALT to 222 U/L, and Alk P to 497 U/L], but bilirubin and enzymes then falling promptly over the next 1-2 weeks). 2903041
Herdeg C, Hilt F, Büchtemann A, Bianchi L, Klein R. Allergic cholestatic hepatitis and exanthema induced by metamizole: verification by lymphocyte transformation test. Liver. 2002;22:507-13. (66 year old man developed truncal rash 12 hours after taking a single dose of metamizole for fever, which became generalized and associated with eosinophilia and liver test abnormalities [bilirubin rising to 1.6 mg/dL, ALT to 636 U/L, Alk P to 719 U/L], treated with corticosteroids and with subsequent slow recovery). 12445177
Contreras J, Poniachik J, Planzer M, Lazarte R, Smok G, Oksenberg D, Madrid AM, Brahm J [Drug induced liver disease: clinical and pathological patterns in 33 cases]. Rev Med Chil. 2003;131:1128-34. Spanish. (Among 33 cases of suspected drug induced liver injury who underwent liver biopsy between 1988 and 2000 at the Clinical Hospital of the University of Chile, two cases were attributed to dipyrone, one was given in combination with piroxicam and one with estradiol and prasterone). 14692302
Hernández N, Bessone F, Sáhez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, two of which were attributed to dipyrone, both from Chile [Contreras 2003]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none of the cases were attributed to metamizole or dipyrone). 25754159
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol. 2015;79:988-99. (A prospective case surveillance study conducted at 51 hospitals in Berlin between 2002 and 2011 enrolled 198 cases of idiopathic acute hepatitis, 13 of 122 outpatient cases were taking metamizole [11%] vs 14 outpatient controls [2%], while rates metamizole exposure in inpatient cases was the same as rates in outpatient controls). 25444550
Huber M, Andersohn F, Sarganas G, Bronder E, Klimpel A, Thomae M, Konzen C, et al. Metamizole-induced agranulocytosis revisited: results from the prospective Berlin Case-Control Surveillance Study. Eur J Clin Pharmacol. 2015;71:219-27. (A prospective surveillance study for agranulocytosis conducted at 51 hospitals in Berlin between 2002 and 2011 enrolled 88 cases, including 26 [30%] at least possibly attributable to metamizole, mostly in women [73%], ages 19 to 82 years, median duration of therapy 6 days, median dose 2.25 g (range .250 to 4.0 g) daily, estimated frequency 1 per million population). 25378038
Kötter T, da Costa BR, Fässler M, Blozik E, Linde K, Jüni P, Reichenbach S, et al. Metamizole-associated adverse events: a systematic review and meta-analysis. PLoS One. 2015;10:e0122918. (Systematic review of safety of metamizole in 3,716 patients in 79 randomized controlled trials, mostly short term studies of pain relief, found similar rates of adverse events from metamizole vs placebo [13.2% vs 14.0%], acetaminophen [15.8% vs 13.9%], and NSAIDS [24.8% vs 27.1%], but lower rates in comparison to opioids [32.2% vs 39.7%] and only unrelated and varied serious adverse events; no cases of agranulocytosis and no mention of hepatotoxicity). 25875821
Krisai P, Rudin D, Grünig D, Scherer K, Pichler W, Terracciano L, Krähenbühl S. Acute liver failure in a patient treated with metamizole. Front Pharmacol. 2019;10:996. (54 year old German woman developed severe hepatitis 2 months after starting metamizole [4 g daily] for postoperative pain [bilirubin 11.4 mg/dL, ALT 3375 U/L, Alk P 586 U/L], which steadily worsened despite stopping the drug with biopsy showing massive necrosis, undergoing liver transplantation 16 days after presentation). 31572180
Lutz M. Metamizole (Dipyrone) and the liver: a review of the literature. J Clin Pharmacol. 2019;59:1433-1442. (Review of the literature on metamizole induced liver injury concludes that “…experimental and clinical studies make some hepatotoxic potential of metamizole at least conceivable”). 31433499
Sebode M, Reike-Kunze M, Weidemann S, Zenouzi R, Hartl J, Peiseler M, Liwinski T, et al. Metamizole: An underrated agent causing severe idiosyncratic drug-induced liver injury. Br J Clin Pharmacol. 2020;86:1406-1415. (Among 151 cases of drug induced liver injury seen at a single German referral center between 2008 and 2017, metamizole was the second most frequently implicated agent with 23 cases [15%], 65% in women, median age 40 years, latency 4 weeks, median ALT at onset 779 U/L, Alk P 131 U/L, bilirubin 1.9 mg/dL [range 0.3-21.1 mg/dL], 2 patients requiring urgent liver transplant, 4 patients had recurrence on reexposure). 32080881
Björnsson ES. Liver injury associated with the analgetic drug metamizole. Br J Clin Pharmacol. 2020;86:1248-1250. (Short review of the liver injury attributed to metamizole, based upon at least 40 reports in the literature, mostly coming from Germany, the typical case being hepatocellular, with positive rechallenges and fatal cases included). 32400058
Weber S, Benesic A, Gerbes AL. Further evidence for the hepatotoxic potential of metamizole. Br J Clin Pharmacol. 2021;87:1587-1588. (Letter in response to Bjornsson [2020] describes 10 cases of liver injury attributed to metamizole captured in a German database [Weber, Drug Safety: 2021]). 32696537
Weber S, Benesic A, Neumann J, Gerbes AL. Liver injury associated with metamizole exposure: features of an underestimated adverse event. Drug Saf. 2021;44:669-680. (Among 238 cases of suspected drug induced liver injury enrolled in a German registry between 2013 and 2020, 32 [13%] were attributed to metamizole, 22 in women [69%], 26 hepatocellular [81%], 5 mixed, and 1 cholestatic, 23 ANA positive [72%], 7 acute liver failure [22%] and 2 had liver transplant [6%], 4 had a positive rechallenge). 33638811
Liu J, Dai XL, Zhou XJ, Gu BH, Yang ZH, Lai J. Metamizole-induced acute liver failure in a boy. Clin Res Hepatol Gastroenterol. 2021;45:101570. (15 year old Chinese male developed chills, fatigue, and jaundice 24 hours after taking a single dose of metamizole [bilirubin 37.3 mg/dL, ALT 8140 U/L, INR 3.0], with rapid improvement once it was stopped and normal values of liver tests 2 months later). 33303406
Hedenmalm K, Pacurariu A, Slattery J, Kurz X, Candore G, Flynn R. Is there an increased risk of hepatotoxicity with metamizole? A comparative cohort study in incident users. Drug Saf. 2021;44:973-985. (Analysis of a German healthcare database from 2009 to 2018 of admissions for liver injury in patients without underlying liver disease prescribed metamizole [n=489,980] or acetaminophen [n=143,871] for the first time and followed for at least a year, found 1723 vs 197 liver injury cases with an increased hazard ratio of 1.69 for metamizole and an estimated rate of 1 per 300 recipients). 34273099
Preveden N, Liechti ME, Oettl T, Erb S. Metamizole as a rare cause of drug-induced Liver injury. Eur J Case Rep Intern Med. 2022;9:003349. (56 year old man developed fever and fatigue within 12 hours of starting metamizole for osteoarthritis, with history of 3 previous similar episodes after taking the drug [bilirubin 1.0 mg/dL, ALT 1374 U/L, Alk P 51 U/L], biopsy showing steatosis, subacute hepatic necrosis, and eosinophilic infiltrates, and rapid improvement on stopping without worsening or jaundice). 35774740
Pohl J, Bischoff P, Oellinger R, Schoening W, Lurje G, Pratschke J, Horst D, et al. Liver transplantation for metamizole induced acute liver failure. Transplant Proc. 2022;54:1854-1858. (Two cases of acute liver failure from a single German referral center presenting in April-May 2021; a 61 year old man and 56 year old woman presented after 3 months and 3 weeks of starting metamizole [2 g daily] for pain [bilirubin 19.5 and 15.2 mg/dL, ALT 446 and 3169 U/L], with rapid worsening and hepatic failure and liver transplant within 6 days; mentions that of 61 cases of metamizole liver injury in the literature, there were 6 reports of death or transplant). 35933233
Schulte B, Tergast TL, Griemsmann M, Menti D, Deveci N, Kahlhöfer J, Dörge P, et al. Metamizole-associated risks in decompensated hepatic cirrhosis. Dtsch Arztebl Int. 2022;119:687-693. (Among 532 adults with decompensated cirrhosis and ascites in a German retrospective cohort, the 110 who were treated for pain with metamizole had a higher, 28-day incidence of acute kidney injury than those receiving other analgesics [68% vs 40%], as well as severe kidney injury [24% vs 9%] and rate of death or liver transplantation [22% and 9%]; results that were duplicated in a prospective cohort of 110 patients). 35912424
Lutz M, Grünewald I, Lenze F, Heinzow H, Ullerich H, Kabar I, Schmidt HH, et al. Unmasking of metamizole-induced liver injury by simultaneous development of characteristic agranulocytosis. Curr Drug Saf. 2023;18:404-412. (22 year old woman developed fever, rash, and jaundice two months after starting over-the-counter metamizole accompanied by low granulocyte counts and ANA and SMA positivity; the agranulocytosis was treated successfully with corticosteroids and granulocyte colony stimulating factor). 35670337
Bock K, Engel B, Jaeckel E, Wedemeyer H, Mederacke I, Mederacke YS. LKM immunofluorescence is associated with dili, especially after metamizole intake. Dig Dis. 2025;43:423-433.. (Among a large cohort of patients screened for liver kidney microsomal antibodies [anti-LKM, directed at cytochrome P450 isoenzymes] by immunofluorescence, 53 of 64 with high titers had drug-induced liver injury, and 33 were attributable to metamizole [median age 38 years, 87% women, 95% hepatocellular, 25% ANA positive, 24% requiring liver transplantation, 3% death, often “autoimmune hepatitis-like”]). 40159290
Weber S, Erhardt F, Allgeier J, Saka D, Donga N, Neumann J, Lange CM, et al. Drug-induced liver injury caused by metamizole: identification of a characteristic injury pattern. Liver Int. 2025;45: e70012.. (Among 324 patients with drug-induced liver injury enrolled between 2012 and 2023 into a German, single-referral center, prospective study, 61 cases [19%] were attributed to metamizole with a median age 44 years, latency 44 days, 69% women, 84% hepatocellular enzyme pattern, 72% with ANA, 25% with AMA, 25% with high IgG levels, fatality rate 13%, and positive rechallenge in 9 cases; a distinctive course was extremely high ALT and rapidly increasing bilirubin levels at presentation with subsequent acute liver failure). 39912769
Mahapatra S, Duggal S, Botros M, Guzma J, Hakim N, Badillo R. Across the border: a metamizole drug-induced liver injury. Cureus. 2025;17:e81010.. (39 year old man developed abdominal pain and jaundice a few weeks after starting a compounded medication obtained in Mexico that contained metamizole [bilirubin 6.5 mg/dL, ALT 2579 U/L, Alk P 130 U/L], the injury resolving once the drug was stopped). 40264611

## OTHER REFERENCE LINKS

Recent References on Metamizole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Metamizole+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Metamizole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Metamizole)